# Cyclizine

## OVERVIEW

### Introduction

Cyclizine and chlorcyclizine are first generation antihistamines that are used largely to treat or prevent motion sickness and nausea. Cyclizine has been linked to very rare instances of clinically apparent acute liver injury.

### Background

Cyclizine (sye' kli zeen) and chlorcyclizine (klor sye' kli zeen) are first generation antihistamines and antiemetics that belong to the piperazine class of these agents (with hydroxyzine and meclizine). Cyclizine and chlorcyclizine are most commonly used to treat the symptoms of nausea, vomiting and dizziness associated with motion sickness. However, they are also used to review symptoms of allergic rhinitis and the common cold, particularly in combination with sympathomimetic agents such as phenylephrine. Cyclizine was first approved for use in the United States in 1966. It is still widely used and is available as tablets or capsules of 25 mg in multiple generic forms and under the trade name Cyclivert and Bonine in both prescription and nonprescription forms. The typical dose is 1 or 2 tablets one hour before travel. Chlorcyclizine is used in a similar dose regimen. Both cyclizine and chlorcyclizine are also available as chewable tablets and in oral liquid formulations as well as combinations with sympathomimetic agents (pseudoephedrine) for the treatment of symptoms of the common cold and nasal congestion. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Despite widespread use, cyclizine and chlorcyclizine have rarely been linked to liver test abnormalities or to clinically apparent liver injury. In an isolated case report, cyclizine was linked to a case of clinically apparent liver injury in a child given the drug for several days to prevent motion sickness. The pattern of liver test abnormalities suggested mild viral hepatitis, but jaundice and symptoms recurred when cyclizine was restarted. There were no immunoallergic features and no evidence for autoimmunity. The reason for the general safety of cyclizine and chlorcyclizine may relate to low daily dose and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cyclizine/Chlorcyclizine – Generic, Cyclivert®, Marezine®/Generic, Bonine®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cyclizine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cyclizine | 82-92-8 | C18-H22-N2 | Cyclizine Chemical Structure
Chlorcyclizine | 82-93-9 | C18-H21-Cl-N2 | Chlorcyclizine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Cyclizine and Chlorcyclizine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cyclizine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cyclizine and Chlorcyclizine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cyclizine)